# Simeprevir

## OVERVIEW

### Introduction

Simeprevir is an oral, direct acting hepatitis C virus (HCV) protease inhibitor that is no longer available but was previously used in combination with other antiviral agents in the treatment of chronic hepatitis C, genotypes 1 and 4, but subsequently was withdrawn. Simeprevir has been linked to isolated, rare instances of mild, acute liver injury during treatment and to occasional cases of hepatic decompensation in patients with preexisting cirrhosis.

### Background

The hepatitis C virus is a small RNA virus that is a major cause of chronic hepatitis, cirrhosis and hepatocellular carcinoma in the United States as well as worldwide. Various approaches to antiviral therapy of chronic hepatitis C have been developed, starting in the 1980s with interferon alfa which was replaced in the 1990s by long acting forms of interferon (peginterferon), to which was added the oral nucleoside analogue, ribavirin. Between 2010 and 2015, several potent oral, direct acting anti-HCV agents were developed and combinations of these found to have marked activity against the virus, allowing for highly effective therapy without use of interferon with treatment courses of 12 to 24 weeks only. These direct acting agents included HCV protease (NS3/4) inhibitors, structural replication complex (NS5A) inhibitors and the HCV RNA polymerase (NS5B) inhibitors.

Simeprevir (sim e' pre vir) was the third HCV protease inhibitor to become clinically available for therapy of hepatitis C. Like other HCV protease inhibitors, simeprevir blocks the activity of the viral encoded protease (HCV nonstructural [NS] region 3/4) that is essential in the posttranslational modification of the viral polypeptide that is cleaved into a series of structural and nonstructural (enzyme) regions. When used by itself, simeprevir results in rapid inhibition of HCV RNA levels, but resistance develops rapidly in a high proportion of patients. When combined with peginterferon and ribavirin, it was shown to provide a sustained inhibition of HCV RNA with a low rate of antiviral resistance. When given for 24 to 48 weeks, triple therapy using simeprevir increased the sustained virological response (SVR) rate from 40% to 50% (peginterferon and ribavirin alone) to 65% to 75% in patients with genotype 1. Even higher rates of response were found when simeprevir was combined with the HCV polymerase inhibitor sofosbuvir in an all-oral, interferon free regimen for 12 weeks. Simeprevir was approved for use in the United States in 2013 for patients with chronic hepatitis C, genotypes 1 and 4, in combination with peginterferon and ribavirin or as an all-oral regimen with sofosbuvir. It was voluntarily withdrawn by the sponsor in 2018 because of availability of other highly effective regimens for hepatitis C consisting of fixed doses in single tablet formulations. Interestingly, simeprevir has been shown to have antiviral activity against SARS-CoV-2 but has not been assessed in clinical cases of COVID-19. Simeprevir was previously available in 150 mg capsules under the brand name Olysio (formerly TMC435), and the recommended dose was 150 mg once daily for 12 weeks. Common side effects included rash, photosensitivity, pruritus, nausea, headache, muscle aches and abdominal discomfort.

### Hepatotoxicity

In large randomized controlled trials, simeprevir was not linked to an increased rate of serum enzyme elevations during treatment or with instances of clinically apparent liver injury. Simeprevir can cause a mild increase in indirect bilirubin and some patients become visibly jaundiced; but the bilirubin elevations were generally mild, transient and not associated with changes in serum aminotransferase or alkaline phosphatase levels. After its approval and more wide scale use, however, simeprevir was implicated in at least one case of an acute hepatitis (Case 1). The latency to onset was 7 weeks and pattern of injury was hepatocellular without immunoallergic or autoimmune features. Recovery was rapid once therapy was stopped.

In addition, simeprevir, in combination with other agents, has been linked to instances of acute, seemingly spontaneous decompensation of HCV related cirrhosis. The role of simeprevir as opposed to the other HCV antivirals used in combination was often unclear. Rates of hepatic decompensation during simeprevir combination therapy of cirrhosis due to hepatitis C was approximately 2% to 3% when combined with peginterferon and ribavirin, and 0.5% to 1.0% when used with sofosbuvir. Because of the risk of decompensation, patients with cirrhosis who are treated with antiviral regimens (both all-oral and interferon based) should be monitored for evidence of worsening liver disease, particularly during the first 4 weeks of treatment. This complication is probably more common in patients with more advanced liver disease, Child’s Class B cirrhosis and those with a previous history of liver decompensation.

In addition, direct acting antiviral therapy of hepatitis C including regimens using simeprevir have been linked to instances of reactivation of hepatitis B with rise or denovo appearance of HBV DNA in serum followed by a flare of hepatitis that can be severe. The rate of reactivation is appreciable in patients with HBsAg and HBV DNA in serum, but also can occur rarely in persons without HBsAg but with anti-HBc in serum. For these reasons, screening for hepatitis B is recommended in patients who are to receive antiviral therapy of chronic hepatitis C.

Likelihood score: B (likely cause of clinically apparent liver injury usually manifesting as hepatic decompensation in patients with preexisting cirrhosis and probable rare cause of reactivation of hepatitis B in susceptible patients).

Mechanism of Injury

The mechanism by which simeprevir might cause liver injury is not known. It is metabolized in the liver largely via the cytochrome P450 system, predominantly CYP 3A and it is an inhibitor of the drug transporters P-glycoprotein and OATP1Ba/3 and the efflux transporters MDR1, MRP2 and BSEP, perhaps accounting for the indirect hyperbilirubinemia that occurs in some patients. Simeprevir is associated with drug-drug interactions and it can raise levels of some statins. The decompensation that occurs with simeprevir combination therapy may be due to a direct effect of the agent, or else represent a usual complication of the rapid eradication of HCV infection. Finally, the episodes of decompensation may be incidental and unrelated to the antiviral therapy.

### Outcome and Management

Combination antiviral regimens with peginterferon and ribavirin are now rarely used, largely because of the superior efficacy and better tolerance of all-oral regimens for hepatitis C. The oral regimen of sofosbuvir and simeprevir, while highly effective, is more expensive than other equally effective oral regimens and simeprevir is no longer available in the United States. Simeprevir in combination with other antiviral agents has been associated with cases of decompensation in patients with preexisting cirrhosis and with reactivation of hepatitis B in patients with ongoing or previous HBV infection.

Because of the risk of hepatic decompensation in patients with preexisting cirrhosis, particularly those with a prior history of hepatic decompensation, regular monitoring is recommended for patients with hepatitis C related cirrhosis undergoing antiviral therapy, particularly during the first 4 weeks. Therapy should be suspended if signs or symptoms of hepatic failure arise such as marked rises in serum bilirubin (both direct and indirect) and any worsening of ascites, hepatic encephalopathy or prolongation of the prothrombin time. Antiviral therapy of hepatitis C is also a risk factor for reactivation of hepatitis B, and screening for HBsAg and anti-HBc before starting antiviral therapy is recommended. Those with evidence of ongoing or previous HBV infection should be treated prophylactically with antiviral agents with potent activity against HBV or monitored with tests for HBV DNA and started on anti-HBV therapy if levels rise.

Drug Class: Antiviral Agents, Hepatitis C Agents, HCV Protease Inhibitors

## CASE REPORTS

### Case 1. Acute hepatitis during therapy of chronic hepatitis C with simeprevir, peginterferon and ribavirin.(1)

A 65 year old Japanese man with chronic hepatitis C, genotype 1b, developed fatigue and abdominal bloating and was found to have worsening of serum aminotransferase levels 49 days after starting triple antiviral therapy with simeprevir [100 mg orally, once daily], peginterferon [100 μg subcutaneously, each week] and ribavirin [400 mg orally, twice daily]. Serum ALT which had fallen on antiviral therapy rose to 768 U/L with a serum bilirubin of 3.3 mg/dL, alkaline phosphatase 171 U/L, INR 1.2 and albumin 3.8 g/dL (Table). He had no previous history of liver disease other than hepatitis C which was attributed to a blood transfusion 45 years previously and for which he had not been previously treated. He also had a history of heavy alcohol use, but had stopped five years previously. His other medical conditions included diabetes for which he was taking voglibose (an alpha glucosidase inhibitor) and glimepiride (a sulfonylurea), and hyperuricemia for which he was taking allopurinol. All of his medications he had taken for more than a year and he denied use of other over-the-counter medications or nutritional or herbal supplements. Physical examination showed no evidence of fever or rash, and an eosinophil count was normal (1.2%). Tests for hepatitis A, B, C and E were negative as were tests for acute EBV and CMV infection. Both ANA and SMA were negative and serum globulins were not elevated. Imaging of the liver by ultrasound showed no evidence of biliary obstruction or masses. A liver biopsy showed evidence of acute hepatocellular injury superimposed upon on chronic hepatitis, but did not suggest autoimmune hepatitis. Antiviral therapy was suspended, and he improved rapidly. One month later, his symptoms had resolved and all liver tests, including ALT levels, were normal. He remained HCV RNA negative and was ultimately considered to have a sustained virologic response despite the early discontinuation of therapy.

#### Key Points

Medication: | Simeprevir, peginterferon and ribavirin
Pattern: | Hepatocellular (R ratio=18)
Severity: | Moderate (jaundice and hospitalization)
Latency: | 7 weeks
Recovery: | 1 month
Other medications: | Ursodiol, voglibose, glimepiride and allopurinol chronically

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | HCV RNA (IU/mL) | Other
Day 0 | 0 | 301 | 185 | 1.6 | 1.3 million | Therapy started
Week 4 | 0 | 23 | | 1.7 | None | Routine monitoring
Week 7 | 0 | 768 | 171 | 3.3 | None | Admission
Week 12 | 5 weeks | 20 | 166 | 1.1 | None | Asymptomatic
Normal Values | | <40 | <360 | <1.2 | None

#### Comment

A man with known chronic hepatitis C for many years developed an asymptomatic worsening of disease with ALT rising to 301 U/L, for which reason he was started on combination therapy of simeprevir with peginterferon and ribavirin, a regimen that was available and approved for use in Japan. He did well for the first six weeks of treatment and was HCV RNA negative when tested at 4 weeks. After 7 weeks, however, he developed nonspecific symptoms of fatigue and was found to have marked elevations in ALT and mild jaundice. Thorough evaluation found no evidence of other forms of liver disease and he was, indeed, still negative for HCV RNA. He improved rapidly once antiviral therapy was stopped and all liver tests had returned to normal one month later. Fortunately, his HCV infection did not relapse and he appeared to have achieved an SVR with other 7 weeks of treatment. This was a very convincing case of liver injury due to the antiviral therapy. Because he was receiving three agents, one cannot say for sure which one was responsible, but attributing it to simeprevir appears appropriate.

### Case 2. Acute hepatic decompensation in a patient with chronic hepatitis C and cirrhosis during therapy with simeprevir and sofosbuvir.(2)

A 56 year old man with chronic hepatitis C, genotype 1a, and Child’s Class B cirrhosis developed worsening fatigue, anorexia and jaundice 4 weeks after starting oral therapy with simeprevir and sofosbuvir. He had a history of excessive alcohol use, but had stopped drinking years before. He had been treated with peginterferon and ribavirin for hepatitis C on two occasions in the past, without a significant response and had undergone transjugular intrahepatic portosystemic stent shunting (TIPSS) two years previously because of refractory ascites and esophageal varices. He was evaluated for liver transplantation, having a MELD score of 17 with serum bilirubin 5.3 mg/dL, ALT 29 U/L, INR not given. He received approval for pretransplant, compassionate use therapy with the oral antiviral regimen of sofosbuvir and simeprevir (doses not provided). He had a rapid virological response becoming HCV RNA negative by week 4. However, the total serum bilirubin level rose concurrently to 6.6 by week 2 and 28.0 mg/dL by week 4, at which point the antiviral drugs were stopped (Table). His MELD score subsequently rose to 36, the INR to 4.4 and he underwent successful emergency liver transplantation 4 weeks after stopping therapy. In follow up, he remained HCV RNA negative, suggesting a SVR despite therapy for only 4 weeks.

#### Key Points

Medication: | Simeprevir and sofosbuvir
Pattern: | Unknown (alkaline phosphatase not given)
Severity: | Fatal (liver transplantation)
Latency: | 4 weeks
Recovery: | None
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Bilirubin (mg/dL) | HCV RNA (IU/mL) | Other
Day 0 | 0 | 29 | 52 | 5.3 | Present | Therapy started
2 Weeks | 0 | | | 6.6
4 Weeks | 0 | 90 | 229 | 28.0 | None
8 Weeks | 4 weeks | Normal | Normal | 14.2 | None | Liver transplantation
Normal Values | | Not Provided | | <1.2 | None

#### Comment

A man with chronic hepatitis C and cirrhosis and a past history of alcoholism presented for a liver transplant evaluation and was found to have advanced liver disease with moderate decompensation (Child’s Class B). He had HCV genotype 1a infection and a history of “null” responses to courses of peginterferon and ribavirin. He was started on an oral regimen of simeprevir and sofosbuvir, which in clinical trials had been shown to yield sustained virological response rates of 73% in patients with Child’s B cirrhosis. Indeed, he rapidly became HCV RNA negative, but had worsening symptoms and jaundice with rises in serum ALT and INR, prompting emergent liver transplantation. Fortunately, the antiviral therapy was successful in eradicating HCV infection and he remained HCV RNA negative thereafter. While somewhat short on details, this case report was reasonably convincing as demonstrating liver injury due to antiviral therapy. The authors attributed the injury to simeprevir, but sofosbuvir was given concurrently making it difficult to attribute the episode to one versus the other agent. Another possibility was that the sudden decompensation was triggered by the rapid clearance of HCV infection, as occurs in some cases of chronic hepatitis B during initiation of antiviral therapy. Finally, the decompensation may have been coincidental and not related to the drugs or antiviral response at all. Several such instances of “spontaneous” hepatic decompensation arising during potent antiviral therapy have been described which argues for careful monitoring of patients with cirrhosis, particularly during the first few weeks of therapy. This case also shows that antiviral therapy of patients with advanced cirrhosis is best left to centers with expertise in managing end stage liver disease and where liver transplantation is available.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Simeprevir – Olysio®

DRUG CLASS

Hepatitis C Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=simeprevir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Simeprevir | 923604-59-5 | C38-H47-N5-O7-S2

## CITED REFERENCES

1 Igawa T, Fushimi S, Matsuo R, Ikeda F, Nouso K, Yoshino T, Nakatsukasa H. (2014). Severe liver injury associated with simeprevir plus pegylated interferon/ribavirin therapy in a patient with treatment-naïve genotype 1b hepatitis C virus: a case report. Clin J Gastroenterol.
2 Stine JG, Intagliata N, Shah NL, Argo CK, Caldwell SH, Lewis JH, Northup PG. (2015). Hepatic decompensation likely attributable to simeprevir in patients with advanced cirrhosis. Dig Dis Sci.

## ANNOTATED BIBLIOGRAPHY

References updated: 07 February 2022

[Abbreviation used: HBV, hepatitis B virus; HCV, hepatitis C virus; DDA, direct acting antiviral agent; SVR, sustained virological response.

Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss oral, direct acting antiviral agents used to treat hepatitis C).
Kim JL, Morgenstern KA, Lin C, Fox T, Dwyer MD, Landro JA, Chambers SP, et al. (1996). Crystal structure of the hepatitis C virus NS3 protease domain complexed with a synthetic NS4A cofactor peptide. Cell. (Report of the crystal structure of the NS3/4 region of HCV with detailed description of the active serine protease catalytic site, the target for subsequent development of specific inhibitors of the HCV protease).
Fried MW, Buti M, Dore GJ, Flisiak R, Ferenci P, Jacobson I, Marcellin P, et al. (2013). Once-daily simeprevir (TMC435) with pegylated interferon and ribavirin in treatment-naïve genotype 1 hepatitis C: the randomized PILLAR study. Hepatology. (Among 388 patients with chronic hepatitis C, genotype 1, randomized to 1 of 5 different regimens of simeprevir vs placebo combined with peginterferon and ribavirin for 24 or 48 weeks, SVR rates higher with simeprevir vs placebo [76% to 86% vs 66%], while side effects were similar in all groups and there were no concurrent increases in serum bilirubin and aminotransferase levels).
Hayashi N, Seto C, Kato M, Komada Y, Goto S. (2014). Once-daily simeprevir (TMC435) with peginterferon/ribavirin for treatment-naïve hepatitis C genotype 1-infected patients in Japan: the DRAGON study. J Gastroenterol. (Among 92 Japanese patients with chronic hepatitis C, genotype 1, treated with simeprevir [50 or 100 mg] vs placebo for 12 or 24 weeks combined with peginterferon and ribavirin for 24 or 48 weeks, the SVR rates were higher with simeprevir [77% to 92% vs 46%], but adverse event rates were similar except for higher rates of mild bilirubin elevations and rash with simeprevir).
Lawitz E, Sulkowski MS, Ghalib R, Rodriguez-Torres M, Younossi ZM, Corregidor A, DeJesus E, et al. (2014). Simeprevir plus sofosbuvir, with or without ribavirin, to treat chronic infection with hepatitis C virus genotype 1 in non-responders to pegylated interferon and ribavirin and treatment-naïve patients: the COSMOS randomised study. Lancet. (Among 167 patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and simeprevir [with or without ribavirin] for 12 or 24 weeks, SVR rates were 90% to 94%; no mention of ALT elevations or hepatotoxicity).
(2014). Simeprevir (Olysio) for chronic hepatitis C. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of simeprevir shortly after its approval in the US as a part of combination therapy of chronic hepatitis C, genotype 1, mentions side effects of rash, photosensitivity, pruritus, nausea, fatigue and dyspnea; simeprevir can cause serum bilirubin elevations, but these are generally mild, transient and in the indirect(unconjugated) fraction and are not associated with ALT elevations or other evidence of liver injury).
Schinazi R, Halfon P, Marcellin P, Asselah T. (2014). HCV direct-acting antiviral agents: the best interferon-free combinations. Liver Int. (Summary of safety and efficacy of various all-oral regimens for therapy of hepatitis C does not discuss hepatic decompensation, hepatotoxicity or ALT elevations during therapy).
Rosenquist Å, Samuelsson B, Johansson PO, Cummings MD, Lenz O, Raboisson P, Simmen K, Vendeville S, et al. (2014). Discovery and development of simeprevir(TMC435), a HCV NS3/4A protease inhibitor. J Med Chem. (Summary of the development of protease inhibitors for treatment of chronic hepatitis C including simeprevir [TMC435], a novel cyclopentane macrocyclic inhibitor identified by screening in HCV NS3 protease assays, application of structure based design and validation in HCV replicon systems).
Forns X, Lawitz E, Zeuzem S, Gane E, Bronowicki JP, Andreone P, Horban A, et al. (2014). Simeprevir with peginterferon and ribavirin leads to high rates of SVR in patients with HCV genotype 1 who relapsed after previous therapy: a phase 3 trial. Gastroenterology. (Among 393 patients with previously treated chronic hepatitis C, genotype 1, who were treated with simeprevir vs placebo [12 weeks] combined with peginterferon and ribavirin [24 or 48 weeks], SVR rates were higher with simeprevir [79% vs 36%] and, except for hyperbilirubinemia and photosensitivity [3.5% vs 0], adverse event rates were similar).
Izumi N, Hayashi N, Kumada H, Okanoue T, Tsubouchi H, Yatsuhashi H, Kato M, et al. (2014). Once-daily simeprevir with peginterferon and ribavirin for treatment-experienced HCV genotype 1-infected patients in Japan: the CONCERTO-2 and CONCERTO-3 studies. J Gastroenterol. (Among 155 patients with previously treated chronic hepatitis C, genotype 1, treated with simeprevir [12 or 24 weeks] and peginterferon with ribavirin [24 or 48 weeks], SVR rates ranged from 36 to 96%; one patient discontinued therapy because of “abnormal hepatic function” and one for erythema multiforme, but few details provided).
Manns M, Marcellin P, Poordad F, de Araujo ES, Buti M, Horsmans Y, Janczewska E, et al. (2014). Simeprevir with pegylated interferon alfa 2a or 2b plus ribavirin in treatment-naive patients with chronic hepatitis C virus genotype 1 infection(QUEST-2): a randomised, double-blind, placebo-controlled phase 3 trial. Lancet. (Among 324 patients with previously untreated chronic hepatitis C, genotype 1, treated with simeprevir vs placebo [12 weeks] combined with peginterferon and ribavirin [24 or 48 weeks], SVR rates were 81% with simeprevir vs 50% with placebo, while adverse event rates were similar except that simeprevir treated patients had higher rate of rash [24% vs 11%] and photosensitivity [4% vs <1%]).
Jacobson IM, Dore GJ, Foster GR, Fried MW, Radu M, Rafalsky VV, Moroz L, et al. (2014). Simeprevir with pegylated interferon alfa 2a plus ribavirin in treatment-naive patients with chronic hepatitis C virus genotype 1 infection (QUEST-1): a phase 3, randomised, double-blind, placebo-controlled trial. Lancet. (Among 394 previously untreated patients with chronic hepatitis C, genotype 1, treated with simeprevir or placebo [12 or 24 weeks] combined with peginterferon and ribavirin [24 to 48 weeks], SVR rates were higher with simeprevir [80% vs 50%], adverse event rates were similar and increases in ALT “were infrequent and similar between the treatment groups” and not associated with bilirubin elevations).
Kumada H, Hayashi N, Izumi N, Okanoue T, Tsubouchi H, Yatsuhashi H, Kato M, et al. (2015). Simeprevir (TMC435) once daily with peginterferon-α-2b and ribavirin in patients with genotype 1 hepatitis C virus infection: The CONCERTO-4 study. Hepatol Res. (Among 79 patients with chronic hepatitis C, genotype 1, treated with simeprevir [12 weeks] and peginterferon and ribavirin [24 or 48 weeks], SVR rates were higher in treatment naïve [92%] and relapse patients [100%] than in previous nonresponders [39%] and no serious liver related adverse events were recorded).
Dieterich D, Rockstroh JK, Orkin C, Gutiérrez F, Klein MB, Reynes J, Shukla U, et al. (2014). Simeprevir (TMC435) with pegylated interferon/ribavirin in patients coinfected with HCV genotype 1 and HIV-1: a phase 3 study. Clin Infect Dis. (Among 106 patients with chronic hepatitis C, genotype 1, and HIV coinfection treated with simeprevir [12 weeks] combined with peginterferon and ribavirin [24 or 48 weeks], the overall SVR rate was 74%, rash occurred in 16%, photosensitivity 2%, moderate bilirubin elevations 2%, but no patient had significant ALT elevations or clinically apparent liver injury).
Manns MP, Fried MW, Zeuzem S, Jacobson IM, Forns X, Poordad F, Peeters M, et al. (2015). Simeprevir with peginterferon/ribavirin for treatment of chronic hepatitis C virus genotype 1 infection: pooled safety analysis from Phase IIb and III studies. J Viral Hepat. (In a pooled analysis of 5 clinical trials of simeprevir vs placebo combined with peginterferon and ribavirin for 24 to 48 weeks in 1464 patients with chronic hepatitis C, genotype 1 [11% with cirrhosis], bilirubin elevations occurred in 8.4% on simeprevir vs 2.8% on placebo, but none were accompanied by serum ALT elevations or evidence of hepatic injury; no liver related severe adverse events or deaths occurred nor any cases of DRESS or Stevens Johnson syndrome).
Stine JG, Intagliata N, Shah NL, Argo CK, Caldwell SH, Lewis JH, Northup PG. (2015). Hepatic decompensation likely attributable to simeprevir in patients with advanced cirrhosis. Dig Dis Sci. (Two men, ages 43 and 56 years, with chronic hepatitis C, genotype 1, and advanced cirrhosis developed progressive liver failure 2 and 4 weeks after starting sofosbuvir and simeprevir [bilirubin rising from 5.3 to 14.2 mg/dL and 9.5 to 25 mg/dL, ALT 90 and 53 U/L, Alk P not provided], one patient undergoing successful liver transplantation and the other dying, both remaining HCV RNA negative despite stopping therapy promptly).
Pearlman BL, Ehleben C, Perrys M. (2015). The combination of simeprevir and sofosbuvir is more effective than that of peginterferon, ribavirin, and sofosbuvir for patients with hepatitis C-related Child's class A cirrhosis. Gastroenterology. (Among 82 patients with chronic hepatitis C and compensated cirrhosis, genotype 1a, who were treated with sofosbuvir and either simeprevir vs peginterferon with ribavirin for 12 weeks, SVR rates were higher with simeprevir [93% vs 75%]; one patient on peginterferon developed hepatic decompensation, but there were no other liver related serious adverse events in either group).
Pungpapong S, Aqel B, Leise M, Werner KT, Murphy JL, Henry TM, Ryland K, et al. (2015). Multicenter experience using simeprevir and sofosbuvir with or without ribavirin to treat hepatitis C genotype 1 after liver transplant. Hepatology. (Among 123 patients with recurrent chronic hepatitis C, genotype 1, after liver transplant who were treated with simeprevir and sofosbuvir with or without ribavirin for 12 weeks, the overall SVR rate was 90% and severe side effects included acute pancreatitis, allergic lung injury and acute urinary obstruction; there were no ALT elevations above 5 times ULN or clinically apparent liver injury).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiviral agents, but all were antiretroviral agents and no case was attributed to the oral direct acting agents used to treat hepatitis C).
Gutierrez JA, Carrion AF, Avalos D, O'Brien C, Martin P, Bhamidimarri KR, Peyton A. (2015). Sofosbuvir and simeprevir for treatment of hepatitis C virus infection in liver transplant recipients. Liver Transpl. (Among 61 patients with recurrent hepatitis C after liver transplantation who were treated with simeprevir and sofosbuvir for 12 weeks, the overall SVR rate was 93%; two patients with cirrhosis developed hepatic decompensation, but no patient died or had hepatic rejection).
Saxena V, Nyberg L, Pauly M, Dasgupta A, Nyberg A, Piasecki B, Winston B, et al. (2015). Safety and Efficacy of simeprevir/sofosbuvir in hepatitis C-infected patients with compensated and decompensated cirrhosis. Hepatology. (Among 156 patients with chronic hepatitis C, genotype 1, and cirrhosis treated with simeprevir and sofosbuvir with or without ribavirin for 12 weeks, overall SVR rates were 91% in compensated vs 73% in decompensated cases, and hepatic decompensation in 20% vs 3%, one patient dying of liver failure, but rates of adverse events were said to be similar to those of matched, untreated subjects).
Collins JM, Raphael KL, Terry C, Cartwright EJ, Pillai A, Anania FA, Farley MM, Hepatitis B. (2015). Virus Reactivation During Successful Treatment of Hepatitis C Virus With Sofosbuvir and Simeprevir. Clin Infect Dis. (2 cases: 55 year old man with chronic hepatitis C, genotype 1, and HBsAg with low levels of HBV DNA [2300 IU/mL] developed jaundice 8 weeks after starting sofosbuvir and simeprevir [bilirubin 12.2 mg/dL, ALT 1495 U/L, INR 1.96, HBV DNA 22 million IU/mL], with resolution within 6 weeks of stopping HCV agents and starting tenofovir and emtricitabine [Case 2]; 57 year old man with chronic hepatitis C, genotype 1a, and anti-HBc without HBsAg developed rising levels of HBV DNA during therapy with sofosbuvir and simeprevir [Pre <20, 2 weeks 353 and 4 weeks 11,255 IU/mL], which fell to undetectable levels within 8 weeks of starting tenofovir with emtricitabine [Truvada], ALT values remaining normal during the episode).
Aqel BA, Pungpapong S, Leise M, Werner KT, Chervenak AE, Watt KD, Murphy JL, et al. (2015). Multicenter experience using simeprevir and sofosbuvir with or without ribavirin to treat hepatitis C genotype 1 in patients with cirrhosis. Hepatology. (Retrospective review of course of 119 patients with chronic hepatitis C, genotype 1, and cirrhosis treated with sofosbuvir and simeprevir with or without ribavirin found overall SVR rate of 78%; bilirubin levels rose above 3 mg/dL in 4 patients, but none developed hepatic decompensation on therapy or had to discontinue treatment early because of liver related adverse events; one patient died of liver failure 6 weeks after completing treatment despite having cleared HCV RNA).
Bailly F, Pradat P, Virlogeux V, Zoulim F. (2015). Antiviral therapy in patients with hepatitis C virus-induced cirrhosis. Dig Dis. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis summarizing the high rate of adverse events including hepatic decompensation and death with peginterferon based regimens combined with boceprevir or telaprevir, and the more effective and better tolerated all oral regimens).
Ferenci P, Kozbial K, Mandorfer M, Hofer H. (2015). HCV targeting of patients with cirrhosis. J Hepatol. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis, suggests that genotype 1 infected patients should receive an all-oral regimen such as the dual regimen of sofosbuvir with ledipasvir, daclatasvir or simeprevir or the triple combination of dasabuvir with ombitasvir and paritaprevir, the major issues being duration of therapy and the role of ribavirin).
Igawa T, Fushimi S, Matsuo R, Ikeda F, Nouso K, Yoshino T, Nakatsukasa H. (2014). Severe liver injury associated with simeprevir plus pegylated interferon/ribavirin therapy in a patient with treatment-naïve genotype 1b hepatitis C virus: a case report. Clin J Gastroenterol. (65 year old man with chronic hepatitis C developed fatigue and serum ALT elevations 50 days after starting simeprevir, peginterferon and ribavirin [bilirubin 3.3 mg/dL, ALT 728 U/L, Alk P 171 U/L, INR 1.2], with rapid improvement on stopping therapy and persistent loss of HCV RNA despite early discontinuation).
Shiffman ML, James AM, Long AG, Alexander PC. (2015). Treatment of chronic HCV with sofosbuvir and simeprevir in patients with cirrhosis and contraindications to interferon and/or ribavirin. Am J Gastroenterol. (Among 120 cirrhotic patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and simeprevir for 12 weeks, the SVR rate was 83%, but 14 patients developed complications of cirrhosis including hyperbilirubinemia in 8, sepsis in 2 [1 dying of multiorgan failure], hepatocellular carcinoma in 2 and variceal hemorrhage in 2).
Ende AR, Kim NH, Yeh MM, Harper J, Landis CS. (2015). Fulminant hepatitis B reactivation leading to liver transplantation in a patient with chronic hepatitis C treated with simeprevir and sofosbuvir: a case report. J Med Case Rep. (59 year old woman with chronic hepatitis C, genotype 1, and anti-HBc without HBsAg or HBV DNA in serum, developed jaundice 11 weeks after starting sofosbuvir and simeprevir [bilirubin 9.1 mg/dL, ALT 2263 U/L, INR 1.9, HBV DNA 29 million IU/mL]; she was started on tenofovir, but developed progressive liver failure and underwent emergency liver transplantation 10 days after presentation).
Lawitz E, Jacobson IM, Nelson DR, Zeuzem S, Sulkowski MS, Esteban R, Brainard D, et al. (2015). Development of sofosbuvir for the treatment of hepatitis C virus infection. Ann N Y Acad Sci. (Review of the development of therapy of hepatitis C, focusing upon sofosbuvir and the prelicensure studies that lead to its approval).
Modi AA, Nazario H, Trotter JF, Gautam M, Weinstein J, Mantry P, Barnes M, et al. (2016). Safety and efficacy of simeprevir plus sofosbuvir with or without ribavirin in patients with decompensated genotype 1 hepatitis C cirrhosis. Liver Transpl. (Among 42 patients with chronic hepatitis C, genotype 1, with decompensated cirrhosis treated with simeprevir and sofosbuvir with vs without ribavirin for 12 weeks, the overall SVR rate was 74% and no patient developed worsening hepatic decompensation or required hospitalization).
European Association for Study of Liver. (2015). EASL Recommendations on Treatment of Hepatitis C 2015. J Hepatol. (Guidelines for the antiviral therapy of chronic hepatitis C from the European liver disease research and academic society).
AASLD/IDSA HCV Guidance Panel. (2015). Hepatitis C guidance: AASLD-IDSA recommendations for testing, managing, and treating adults infected with hepatitis C virus. Hepatology. (Guidelines for the antiviral therapy of chronic hepatitis C from the US liver and infectious diseases research and academic societies).
Lawitz E, Matusow G, DeJesus E, Yoshida EM, Felizarta F, Ghalib R, Godofsky E, et al. (2016). Simeprevir plus sofosbuvir in patients with chronic hepatitis C virus genotype 1 infection and cirrhosis: A Phase 3 study (OPTIMIST-2). Hepatology. (Among 103 patients with chronic hepatitis C, genotype 1, and cirrhosis treated with sofosbuvir and simeprevir for 12 weeks 103 [83%] had an SVR, and no patient developed liver failure or a treatment related serious adverse event).
Kamar N, Marion O, Rostaing L, Cointault O, Ribes D, Lavayssière L, Esposito L, et al. (2016). Efficacy and safety of sofosbuvir-based antiviral therapy to treat hepatitis C virus infection after kidney transplantation. Am J Transplant. (Among 25 kidney transplant recipients with chronic hepatitis C, genotype 1, treated with sofosbuvir in combination with other antiviral agents, 22 [88%] had an SVR, and "no adverse event was observed").
Crittenden NE, Buchanan LA, Pinkston CM, Cave B, Barve A, Marsano L, McClain CJ, et al. (2016). Simeprevir and sofosbuvir with or without ribavirin to treat recurrent genotype 1 hepatitis C virus infection after orthotopic liver transplantation. Liver Transpl. (Among 56 patients with recurrent hepatitis C after liver transplantation who were treated with sofosbuvir and simeprevir for 12 weeks, 49 [88%] had an SVR, and two died of liver failure).
Issa D, Eghtesad B, Zein NN, Yerian L, Cruise M, Alkhouri N, Adams R, et al. (2016). Sofosbuvir and simeprevir for the treatment of recurrent hepatitis C with fibrosing cholestatic hepatitis after liver transplantation. Int J Organ Transplant Med. (Among 5 patients with recurrent hepatitis C and fibrosing cholestatic hepatitis after liver transplant who were treated with sofosbuvir and simeprevir for 24 weeks, 4 had an SVR with resolution of jaundice, and one developed hepatic decompensation and died).
Pillai AA, Wedd J, Norvell JP, Parekh S, Cheng N, Young N, Spivey JR, et al. (2016). Simeprevir and sofosbuvir (SMV-SOF) for 12 weeks for the treatment of chronic hepatitis C genotype 1 infection: a real world (transplant) hepatology practice experience. Am J Gastroenterol. (Among 170 patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and simeprevir with or without ribavirin for 12 weeks in routine clinical practice, 133 [78%] had an SVR; adverse events were not discussed).
Brown RS, O'Leary JG, Reddy KR, Kuo A, Morelli GJ, Burton JR, Stravitz RT, et al. (2016). Hepatitis C Therapeutic Registry Research Network Study Group. Interferon-free therapy for genotype 1 hepatitis C in liver transplant recipients: Real-world experience from the hepatitis C therapeutic registry and research network. Liver Transpl. (Among 151 patients with recurrent hepatitis C after liver transplantation treated with sofosbuvir and simeprevir with or without ribavirin for 12 or 24 weeks, 133 [88%] had an SVR, and 8 [5%] developed hepatic decompensation and 3 patients died, all of whom had cirrhosis).
Sulkowski MS, Vargas HE, Di Bisceglie AM, Kuo A, Reddy KR, Lim JK, Morelli G, et al., HCV-TARGET Study Group. (2016). Effectiveness of simeprevir plus sofosbuvir, with or without ribavirin, in real-world patients with HCV genotype 1 infection. Gastroenterology. (Among 802 patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and simeprevir with or without ribavirin for 12 weeks in clinical practices ["the real world"], 675 [84%] had an SVR, 44 [5.3%] had a serious adverse event, 10 [1.2%] hepatic decompensation and 2 [0.3%] died of liver failure).
Modi AA, Nazario H, Trotter JF, Gautam M, Weinstein J, Mantry P, Barnes M, et al. (2016). Safety and efficacy of simeprevir plus sofosbuvir with or without ribavirin in patients with decompensated genotype 1 hepatitis C cirrhosis. Liver Transpl. (Among 42 patients with chronic hepatitis C, genotype 1, and decompensated cirrhosis treated with sofosbuvir, simeprevir and [n=35] ribavirin for 12 weeks, 31 [74%] had an SVR, and none developed decompensation requiring hospitalization).
Fontana RJ, Brown RS, Moreno-Zamora A, Prieto M, Joshi S, Londoño MC, et al. (2016). Daclatasvir combined with sofosbuvir or simeprevir in liver transplant recipients with severe recurrent hepatitis C infection. Liver Transpl. (Among 97 liver transplant recipients treated with daclatasvir and either sofosbuvir or simeprevir with or without ribavirin for up to 24 weeks, 84 [87%] had an SVR, and 8 [8%] patients died, but none of the deaths were considered due to the antiviral therapy).
Dyson JK, Hutchinson J, Harrison L, Rotimi O, Tiniakos D, Foster GR, Aldersley MA, et al. (2016). Liver toxicity associated with sofosbuvir, an NS5A inhibitor and ribavirin use. J Hepatol. (74 year old man and 36 year old woman with HCV related cirrhosis developed worsening hepatic decompensation within a few weeks of starting sofosbuvir, an NS5A inhibitor and ribavirin [peak bilirubin 23.4 and 30.5 mg/dL, ALT 65 and 96 U/L, Alk P 202 and 398 U/L], resulting in death in one and emergency liver transplant in the other [Case 1]).
Marchan-Lopez A, Dominguez-Dominguez L, Kessler-Saiz P, Jarrin-Estupiñan ME. (2016). Liver failure in human immunodeficiency virus - hepatitis C virus coinfection treated with sofosbuvir, ledipasvir and antiretroviral therapy. J Hepatol. (Letter in response to Dyson [2016]: 49 year old man with chronic hepatitis C, cirrhosis [Child-Pugh class B] and HIV coinfection developed worsening hepatic decompensation 1 to 2 months after starting sofosbuvir and ledipasvir that worsened for two weeks after stopping [peak bilirubin 46.9 mg/dL, INR 3.17], and then resolved; he later tolerated reinitiation of antiretroviral drugs).
Dyson JK, McPherson S. (2016). Reply to "Liver failure in human immunodeficiency virus - Hepatitis C virus coinfection treated with sofosbuvir, ledipasvir and antiretroviral therapy". J Hepatol. (Letter in reply to March-Lopez [2016] reporting another case of hepatic decompensation during sofosbuvir, ledipasvir and ribavirin therapy of a patient hepatitis C, cirrhosis and HIV coinfection, arising within 6 weeks of starting treatment [bilirubin 12.6 mg/dL, protime 17 sec], and leading to successful, emergency liver transplantation).
Welker MW, Luhne S, Lange CM, Vermehren J, Farnik H, Herrmann E, Welzel T, et al. (2016). Lactic acidosis in patients with hepatitis C virus cirrhosis and combined ribavirin/ sofosbuvir treatment. J Hepatol. (Among 35 patients with chronic hepatitis C and advanced fibrosis or cirrhosis treated with sofosbuvir based regimens, 12 [34%] had a serious adverse event and 5 [14%] developed lactic acidosis, largely in those with Child-Pugh class B or C cirrhosis and in the context of hepatic decompensation, 2 of whom died).
(2016). In brief: Hepatitis B reactivation with direct-acting antiviral drugs for hepatitis C. Med Lett Drugs Ther. (Brief summary of the FDA warning letter concerning HBV reactivation caused by DAA therapies of hepatitis C).
Hoofnagle JH. (2016). Hepatic decompensation during direct-acting antiviral therapy of chronic hepatitis C. J Hepatol. (Editorial in response to Welker [2016] discussing the occurrence of unexplained hepatic decompensation during antiviral therapy of hepatitis C and whether these episodes are coincidental, caused by hepatoxicity of the antiviral drugs, or are the paradoxical result of sudden eradication of the chronic viral infection).
Bersoff-Matcha SJ, Cao K, Jason M, Ajao A, Jones SC, Meyer T, Brinker A. (2017). Hepatitis B virus reactivation associated with direct-acting antiviral therapy for chronic hepatitis C virus: a review of cases reported to the U.S. Food and Drug Administration adverse event reporting system. Ann Intern Med. (FDA summary of 29 reports of HBV reactivation among patients with chronic hepatitis C being treated with DAAs, including, presenting 14 to 196 days after starting therapy, with various DAA regimens, 3 resulting in death, 19 from Japan, 5 from the U.S., many treated after a delay in identifying the cause of sudden worsening of liver disease).
Mahale P, Glenn JS, O'Brien TR. (2017). Hepatitis B virus reactivation associated with direct-acting antiviral therapy for chronic hepatitis C virus. Ann Intern Med. (Letter in response to Bersoff-Matcha [2017] suggesting that some cases of sudden worsening of liver disease in HBsAg positive patients might be due to superinfections with hepatitis D [Delta] virus).
Bersoff-Matcha SJ, Cao K, Jason M, Jones SC, Brinker A. (2017). Hepatitis B virus reactivation associated with direct-acting antiviral therapy for chronic hepatitis C virus. Ann Intern Med. (Reply to the letter to the editor by Mahale [2017] by the authors).
Serper M, Forde KA, Kaplan DE. (2018). Rare clinically significant hepatic events and hepatitis B reactivation occur more frequently following rather than during direct-acting antiviral therapy for chronic hepatitis C: Data from a national US cohort. J Viral Hepat. (Analysis of the large VA Medical system database of 17,400 veterans with chronic hepatitis C as well as anti-HBc who received oral DAA therapy, identified only 2 cases of HBV reactivation with serum ALT elevations above 300 U/L among 97 HBsAg positive patients).
Aggeletopoulou I, Konstantakis C, Manolakopoulos S, Triantos C. (2017). Risk of hepatitis B reactivation in patients treated with direct-acting antivirals for hepatitis C. World J Gastroenterol. (Review of the literature on reactivation of HBV during antiviral therapy of chronic hepatitis C summarizing 7 cases in the literature).
Calvaruso V, Ferraro D, Licata A, Bavetta MG, Petta S, Bronte F, Colomba G, et al. (2018). HBV reactivation in patients with HCV/HBV cirrhosis on treatment with direct-acting antivirals. J Viral Hepat. (Among 104 patients with cirrhosis and chronic hepatitis C who were treated with DAAs, reactivation of HBV occurred in 3 of 4 HBsAg positive patients not on anti-HBV therapy, but none developed ALT elevations or clinically apparent acute liver injury).
Loggi E, Gitto S, Galli S, Minichiello M, Conti F, Grandini E, Scuteri A, et al. (2017). Hepatitis B virus reactivation among hepatitis C patients treated with direct-acting antiviral therapies in routine clinical practice. J Clin Virol. (Among 137 Italian adults with chronic hepatitis C treated with DAAs during a one-year period, reactivation [without ALT elevations] occurred in 1 of 2 subjects with HBsAg, but in none of 42 with anti-HBc without HBsAg).
Kawagishi N, Suda G, Onozawa M, Kimura M, Maehara O, Ito J, Nakai M, et al. (2017). Hepatitis B virus reactivation during hepatitis C direct-acting antiviral therapy in patients with previous HBV infection. J Hepatol. (Letter describing course of 5 of 84 patients with chronic hepatitis C and serologic evidence of previous HBV infection [anti-HBc without HBsAg] developed evidence of HBV reactivation during various DAA regimens that was not accompanied by ALT elevations, but was persistent after DAA treatment in two patients).
Belperio PS, Shahoumian TA, Mole LA, Backus LI. (2017). Evaluation of hepatitis B reactivation among 62,920 veterans treated with oral hepatitis C antivirals. Hepatology. (Analysis of VA Medical Database of 62,920 veterans with chronic hepatitis C treated with oral DAAs of whom 9 had evidence of HBV reactivation, 8 in patients with HBsAg and 1 with anti-HBc without HBsAg in serum, but only 3 patients had ALT elevations above twice ULN).
Yeh ML, Huang CF, Hsieh MH, Ko YM, Chen KY, Liu TW, Lin YH, et al. (2017). Reactivation of hepatitis B in patients of chronic hepatitis C with hepatitis B virus infection treated with direct acting antivirals. J Gastroenterol Hepatol. (Among 64 patients with chronic hepatitis C and serologic evidence of ongoing or previous HBV infection who were treated with various DAA regimens, 4 of 7 HBsAg positive [57%] but none of 57 anti-HBc positive, HBsAg negative subjects developed HBV reactivation but all cases were subclinical, ALT elevations occurring in only one).
Londoño MC, Lens S, Mariño Z, Bonacci M, Ariza X, Broquetas T, Pla A, et al. (2017). Hepatitis B reactivation in patients with chronic hepatitis C undergoing anti-viral therapy with an interferon-free regimen. Aliment Pharmacol Ther. (Among 352 patients with chronic hepatitis C receiving DAA treatment, 5 of 10 [50%] with concurrent HBsAg and 1 of 64 with anti-HBc without HBsAg developed a 1 log IU/mL increase in HBV DNA levels, but elevations were modest and none developed ALT elevations or clinically apparent liver injury).
Kawagishi N, Suda G, Onozawa M, Kimura M, Maehara O, Ohara M, Izumi T, et al. (2017). Comparing the risk of hepatitis B virus reactivation between direct-acting antiviral therapies and interferon-based therapies for hepatitis C. J Viral Hepat. (Among 151 patients with chronic hepatitis C undergoing antiviral therapy, reactivation of HBV occurred in 1 of 4 patients with HBsAg in serum, and 5 of 151 with anti-HBc without HBsAg, but peak HBV DNA levels were low and all cases were without ALT elevations or symptoms and all 6 occurred in 79 patients receiving oral DAAs [8%] and none in the 72 who received interferon-based therapies [0%]).
Mücke VT, Mücke MM, Peiffer KH, Weiler N, Welzel TM, Sarrazin C, Zeuzem S, et al. (2017). No evidence of hepatitis B virus reactivation in patients with resolved infection treated with direct-acting antivirals for hepatitis C in a large real-world cohort. Aliment Pharmacol Ther. (Among 848 patients with chronic hepatitis C treated in the "real world" with DAAs, 5 of 9 patients with HBsAg developed HBV reactivation [3 ultimately requiring anti-HBV therapy] and 8 of 263 patients with anti-HBc without HBsAg had low, but detectable levels of HBV DNA during therapy but without ALT elevations).
Lawitz E, Poordad F, Gutierrez JA, Kakuda TN, Picchio G, Beets G, Vandevoorde A, et al. (2017). Simeprevir, daclatasvir and sofosbuvir for hepatitis C virus-infected patients with decompensated liver disease. J Viral Hepat. (Among 40 patients with chronic hepatitis C, genotype 1 or 4, and cirrhosis treated with sofosbuvir, simeprevir and daclatasvir for 12 weeks, all patients achieved an SVR and while 2 patients had an episode of decompensation on treatment and Child’s Pugh scores worsened in 7 patients, there were no deaths and no early discontinuations).
Hézode C, Almasio PL, Bourgeois S, Buggisch P, Brown A, Diago M, Horsmans Y, et al. (2017). Simeprevir and daclatasvir for 12 or 24 weeks in treatment-naïve patients with hepatitis C virus genotype 1b and advanced liver disease. Liver Int. (Among 106 adults with chronic hepatitis C, genotype 1, and advanced liver disease treated with simeprevir and daclatasvir for 12 or 24 weeks, the overall SVR rate was 92% with both 12 and 24 weeks of treatment, 70% had adverse events, 6% serious adverse events but there was only one severe liver related event, a transient and asymptomatic rise in ALT and AST levels above 5 times ULN).
Gaeta GB, Aghemo A, Menzaghi B, D'Offizi G, Giorgini A, Hasson H, Brancaccio G, et al., STIly Study Group. (2018). Effectiveness and safety of simeprevir-based regimens for hepatitis C in Italy: The STIly observational study. Medicine (Baltimore). (Among 342 Italian patients with chronic hepatitis C [genotypes 1 and 4] treated with 12 weeks of sofosbuvir and simeprevir with or without ribavirin, the overall SVR rate was 95% while serious adverse events arose in 1.2%, but all resolved without need for drug discontinuations; no mention of liver injury, hepatitis or ALT elevations).
Miotto N, Mendes LC, Zanaga LP, Lazarini MSK, Goncales ESL, Pedro MN, Goncales FL, Stucchi RSB, et al. (2018). All-oral direct antiviral treatment for hepatitis C chronic infection in a real-life cohort: The role of cirrhosis and comorbidities in treatment response. PLoS One. (Among 527 Brazilian patients with chronic hepatitis C treated with interferon free regimens [including sofosbuvir, daclatasvir, ribavirin and simeprevir] between 2015 and 2018, the overall SVR rate was 91% and 22 of 272 patients [8%] with cirrhosis had decompensation during therapy).
Sulkowski MS, Feld JJ, Lawitz E, Felizarta F, Corregidor AM, Khalid O, Ghalibv R, et al. (2018). Efficacy and safety of 6 or 8 weeks of simeprevir, daclatasvir, sofosbuvir for HCV genotype 1 infection. J Viral Hepat. (Among 68 adults with chronic hepatitis C, genotype 1, treated with simeprevir, daclatasvir and sofosbuvir for either 6 weeks [mild fibrosis] or 8 weeks [cirrhosis], the SVR rate was 86% in the 6 week and 100% in the 8 week arm, but relapse was frequent [12%]; there were no therapy related serious adverse events or elevations of serum ALT above 5 times ULN).
Pariente A, Arpurt JP, Rémy AJ, Rosa-Hézode I, Causse X, Heluwaert F, Macaigne G, et al. (2019). Association nationale des gastroentérologues des hôpitaux (ANGH). Hepatitis C treatment with all-oral direct-acting antivirals: Effectiveness and tolerance in a multicenter, prospective, observational study from French general hospitals (APROVVIE, ANGH). Presse Med. (Among 1123 patients with chronic hepatitis C treated at 24 French general hospitals with various interferon-free antiviral regimens for 12 or 24 weeks the overall response rate was 91%, with lower responses among 553 patients with cirrhosis, two of whom developed hepatic decompensation and died).
Laurain A, Metivier S, Haour G, Larrey D, Dorival C, Hezode C, Zoulim F, et al., ANRS/AFEF HEPATHER study group. (2019). Safety and efficacy of the combination simeprevir-sofosbuvir in HCV genotype 1- and 4-mono-infected patients from the French ANRS CO22 hepather cohort. BMC Infect Dis. (Among 599 French patients with chronic hepatitis C [genotypes 1 and 4] treated with 12 or 24 weeks of sofosbuvir and simeprevir with or without ribavirin, the overall SVR rate was 93%, while serious adverse events arose in 37 [9%] participants, one of which was drug induced liver injury; 4 patients died, but none from liver disease).
Gammeltoft KA, Zhou Y, Duarte Hernandez CR, Galli A, Offersgaard A, Costa R, Pham LV, et al. (2021). Hepatitis C virus protease inhibitors show differential efficacy and interactions with remdesivir for treatment of SARS-CoV-2 in vitro. Antimicrob Agents Chemother. (In a cell culture system, simeprevir and several other HCV protease inhibitors demonstrated antiviral activity against SARS-CoV-2, which was synergist with remdesivir).

## OTHER REFERENCE LINKS

1 Recent References on Simeprevir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Simeprevir+AND+isoxazoles/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Simeprevir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Simeprevir)

[Jim: Check the links]